# Cysteamine

## OVERVIEW

### Introduction

Cysteamine is a simple aminothiol molecule that is used to treat nephropathic cystinosis, due to its ability to decrease the markedly elevated and toxic levels of intracellular cystine that occur in this disease and cause its major complications. Cysteamine has been associated with serum enzyme elevations when given intravenously in high doses, but it has not been shown to cause clinically apparent acute liver injury.

### Background

Cysteamine (sis tee' a meen) is a simple aminothiol molecule which is used to treat nephropathic cystinosis, a rare autosomal recessive disorder characterized by progressive renal tubular dysfunction and growth retardation, and which eventually leads to renal failure and need for dialysis or renal transplantation often within the first decade of life. The underlying defect in cystinosis is a deficiency of an amino acid carrier that transports cystine out of lysosomes. The absence of this transporter causes accumulation of toxic levels of cystine in tissues. Those organs most susceptible to the toxic effects of cystine include the kidney, endocrine tissue, eyes and muscle. Cysteamine readily penetrates cells and is concentrated in lysosomes where it acts by converting intralysosomal cystine to cysteine which is readily transported out of lysosomes. This action leads to a decrease in cellular cystine levels and prevents the renal failure, growth retardation and many of the other chronic complications of nephropathic cystinosis. Cysteamine was approved for the therapy of cystinosis in the United States in 1994. It is now available in several forms including cysteamine bitartrate salt under the commercial name Cystagon (given every 6 hours), as well as a delayed release preparation under the name ProCysBi (given every 12 hours). The typical maintenance dose is 2.0 grams daily in adults and children above the age of 12, and 1.3 to 1.95 grams/m^2^ daily in younger children. Cysteamine is usually initiated using a fraction of the maintenance dose, with gradual dose escalation. Both preparations of cysteamine have an unpleasant taste and odor which makes compliance with taking the high doses required to control intracellular cystine levels in cystinosis a frequent problem. Common side effects include nausea, anorexia, fatigue and diarrhea. Rare, but potentially severe adverse reactions include rash, skin fragility and benign intracranial hypertension. Joint hyperextension, leg pains, osteopenia, fractures and scoliosis also occur in cysteamine treated patients with cystinosis, but are more likely complications of the underlying disease than adverse effects due to cysteamine.

### Hepatotoxicity

During long term use of cysteamine in preregistration studies, serum ALT elevations occurred in a small proportion of treated subjects, but the background rate of serum enzyme elevations in this population is high and was not defined in the open label studies. There have been reports of more marked enzyme elevations during high dose therapy with cysteamine, with recurrence on reexposure. These abnormalities were invariably asymptomatic and rapidly reversed with dose adjustment. In addition, patients with cystinosis appear to be at risk for developing nodular regenerative hyperplasia and noncirrhotic portal hypertension. The role of long term cysteamine therapy in these hepatic complications is not clear. There have been no reports of clinically apparent, acute liver injury with jaundice attributable to cysteamine, although it has had only limited wide scale use.

Likelihood score: D[HD] (possible cause of liver injury when given in high doses).

### Mechanism of Injury

The mechanism by which cysteamine might lead to serum enzyme elevations or liver injury is not known. Cysteamine is metabolized in most cells and it does not seem to be a substrate for or affect the hepatic cytochrome P450 system. In clinical trials of cysteamine, no evidence of drug-drug interactions was identified.

### Outcome and Management

Serum enzyme elevations during cysteamine therapy are generally mild and self-limited, resolving even without drug interruption or dose reduction. Other causes of liver injury should be sought before assuming that the abnormalities are due to cysteamine.

Drug Class: Genetic Disorder Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cysteamine Bitartrate – Cystagon®

Cysteamine Bitartrate (Delayed Release) – ProCysBi®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cysteamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cysteamine | 27761-19-9 | C4-H6-O6.C2-H7-N-S | Cysteamine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 November 2017

Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; cysteamine is not discussed).
Gahl WA, Bashan N, Tietze F, Bernardini I, Schulman JD. Cystine transport is defective in isolated leukocyte lysosomes from patients with cystinosis. Science 1982; 217 (4566): 1263-5. (Demonstration of defective transporter for cystine in lysosomes from patients with cystinosis which results in a toxic accumulation of cystine; in contrast, the egress of methionine, tryptophan and other amino acids is normal, suggesting a specific amino acid transporter defect). 7112129
Avner ED, Ellis D, Jaffee R. Veno-occlusive disease of the liver associated with cysteamine treatment of nephropathic cystinosis. J Pediatr 1983; 102: 793-6. (8 year old boy with nephropathic cystinosis developed ascites and gastrointestinal bleeding from gastric varices 22 months after starting cysteamine [bilirubin not given, ALT 16 U/L, Alk P 68 U/L, protime 19 sec], biopsy showing changes of sinusoidal obstruction syndrome). 6842343
Gahl WA, Schulman JD, Thoene JG, Schneider J. Hepatotoxicity of cysteamine? J Pediatr 1983; 103: 1008-9. (Letter in response to Avner [1983] suggesting that sinusoidal obstruction syndrome may be a part of the clinical spectrum of cystinosis, rather than a complication of cysteamine therapy). 6644413
Gahl WA, Schneider JA, Thoene JG, Chesney R. Course of nephropathic cystinosis after age 10 years. J Pediatr 1986; 109: 605-8. (Among 80 patients with nephropathic cystinosis above the age of 10 identified in a US wide survey, 90% had undergone renal transplant [at an average age of 10 years] and the oldest child without transplant was 14 and on dialysis; other complications included hepatomegaly [42%] and splenomegaly, but liver tests were abnormal in only 11 [14%] who had mild ALT or AST elevations; other late complications included photophobia, decreased visual acuity and hypothyroidism). 3531450
Gahl WA, Reed GF, Thoene JG, Schulman JD, Rizzo WB, Jonas AJ, Denman DW, et al. Cysteamine therapy for children with nephropathic cystinosis. N Engl J Med 1987; 316: 971-7. (Among 93 children with nephropathic cystinosis treated with cysteamine hydrochloride [mean dose 51 mg/kg daily] for up to 6 years, leucocyte cystine concentrations decreased by 82%, renal function stabilized and growth was improved in comparison to historical controls who were not treated; side effects included nausea [from its taste and odor] and one child developed sinusoidal obstruction syndrome which was attributed to the underlying disease, rather than cysteamine). 3550461
Gahl WA, Thoene JG, Schneider JA, O'Regan S, Kaiser-Kupfer MI, Kuwabara T. NIH conference. Cystinosis: progress in a prototypic disease. Ann Intern Med 1988; 109: 557-69. (Review of the clinical characteristics, epidemiology, pathogenesis, complications and therapy of cystinosis). 3048161
Kimonis VE, Troendle JR, Rose SR, Yang ML, Markello TC, Gahl WA. Effects of early cysteamine therapy on thyroid function and growth in nephropathic cystinosis. J Clin Endocrinol Metab 1995; 80: 3257-61. (Among 101 patients with nephropathic cystinosis treated with cysteamine, those started on therapy before the age of 2 and who maintained optimal leukocyte cystine levels [n=24] had lower rates of hypothyroidism and better growth and bone age than those with partial [n=36] or poor or delayed [n=47] treatment responses). 7593434
Gahl WA, Thoene JG, Schneider JA. Cystinosis. N Engl J Med 2002; 347: 111-21. (Review of the history, clinical characteristics, clinical variants, complications, genetics, diagnosis and treatment of cystinosis). 12110740
Kleta R, Gahl WA. Pharmacological treatment of nephropathic cystinosis with cysteamine. Expert Opin Pharmacother 2004; 5: 2255-62. (Review of cysteamine therapy of cystinosis; states that early diagnosis and therapy with cysteamine can guarantee normal growth and maintenance of renal function). 15500372
Kleta R, Bernardini I, Ueda M, Varade WS, Phornphutkul C, Krasnewich D, Gahl WA. Long-term follow-up of well-treated nephropathic cystinosis patients. J Pediatr 2004; 145: 555-60. (Long term course of two siblings with cystinosis who were started on cysteamine therapy at 2 and 20 months of age, and both achieved normal growth and maintained normal renal function [creatinine clearance of 78 and 105 mL/min] for 8 and 12 years). 15480385
Kleta R, Kaskel F, Dohil R, Goodyer P, Guay-Woodford LM, Harms E, Ingelfinger JR, et al.; NIH Office of Rare Diseases. First NIH/Office of Rare Diseases Conference on Cystinosis: past, present, and future. Pediatr Nephrol 2005; 20: 452-4. (Brief summary of the major clinical challenges in cystinosis including early diagnosis, improved therapeutics, better compliance and transition of care from pediatric to adult medical services). 15747161
O'Brien K, Hussain N, Warady BA, Kleiner DE, Kleta R, Bernardini I, Heller T, et al. Nodular regenerative hyperplasia and severe portal hypertension in cystinosis. Clin Gastroenterol Hepatol 2006; 4: 387-94. (Two adults, ages 19 and 30 years, with nephropathic cystinosis but minimal exposure to cysteamine were found to have severe noncirrhotic portal hypertension, and liver biopsies demonstrated nodular regenerative hyperplasia with minimal portal fibrosis, the etiology of which was unknown). 16527704
Gahl WA, Balog JZ, Kleta R. Nephropathic cystinosis in adults: natural history and effects of oral cysteamine therapy. Ann Intern Med 2007; 147: 242-50. (Among 100 adults with nephropathic cystinosis, 92 had a kidney transplants and at least half had hypothyroidism, hypergonadism, pulmonary insufficiency, swallowing disorders and myopathy, one-third had retinopathy and one quarter diabetes; cysteamine therapy was associated with delay in need for renal allograft and fewer complications and deaths). 17709758
Bendel-Stenzel MR, Steinke J, Dohil R, Kim Y. Intravenous delivery of cysteamine for the treatment of cystinosis: association with hepatotoxicity. Pediatr Nephrol 2008; 23: 311-5. (Two year old girl with severe nephropathic cystinosis and intolerance to oral cysteamine was treated with an intravenous form [5-6 mg/kg every 8 hours] which resulted in decreases in intracellular cystine, but was followed after 50 days by marked elevations in serum ALT [2117 U/L] and AST [1362 U/L] without jaundice [bilirubin 0.4 mg/dL], levels promptly falling on stopping the infusions and recurring with intravenous rechallenge [ALT ~140 U/L after 25 days], and later with oral rechallenge using cysteamine bitartrate [ALT 249 U/L after 6 months]). 17668247
Besouw MT, Bowker R, Dutertre JP, Emma F, Gahl WA, Greco M, Lilien MR, et al. Cysteamine toxicity in patients with cystinosis. J Pediatr 2011; 159: 1004-11. (Among 550 European patients with cystinosis who were treated with cysteamine, 8 developed possible toxicity, 6 of whom developed vascular lesions over the elbow marked by irregular collagen fibers and angioendotheliomatosis, other complications were leg pains and neurologic symptoms which improved with lowering the dose; possibly due to inhibition of cross linking of collagen). 21784456
Dohil R, Schmeltzer S, Cabrera BL, Wang T, Durelle J, Duke KB, Schwimmer JB, et al. Enteric-coated cysteamine for the treatment of paediatric non-alcoholic fatty liver disease. Aliment Pharmacol Ther 2011; 33: 1036-44. (Among 11 children [>10 years] with nonalcoholic fatty liver disease and raised serum ALT levels treated with enteric coated cysteamine [15 mg/kg daily], mean ALT levels fell [from 120 to 55 U/L], with no change in weight and rise of ALT values after stopping therapy [to 74 U/L). 21395631
Langman CB, Greenbaum LA, Sarwal M, Grimm P, Niaudet P, Deschênes G, Cornelissen E, et al. A randomized controlled crossover trial with delayed-release cysteamine bitartrate in nephropathic cystinosis: effectiveness on white blood cell cystine levels and comparison of safety. Clin J Am Soc Nephrol 2012; 7: 1112-20. (Among 43 patients with cystinosis treated with standard cysteamine [every 6 hours] or a new formulation of enteric coated, delayed release form of cysteamine bitartrate [every 12 hours] for 3 weeks with subsequent cross over, mean peak white cell cystine levels were similar, but gastrointestinal side effects were greater with the delayed release form). 22554716
Schwimmer JB, Lavine JE, Wilson LA, Neuschwander-Tetri BA, Xanthakos SA, Kohil R, Barlow S, et al. In children with nonalcoholic fatty liver disease, cysteamine bitartrate delayed-release improves liver enzymes but does not reduce disease activity scores. Gastroenterol 2016: 151: 1141-54. (Among 169 children with nonalcoholic fatty liver treated with cysteamine [150 to 450 mg daily] or placebo for 48 weeks, ALT and AST levels improved significantly, but histologic changes were minimal; no patient developed clinically worsening or clinically apparent liver injury). 27569726

## OTHER REFERENCE LINKS

1. Recent References on Cysteamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cysteamine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cysteamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cysteamine)